# Saw Palmetto

## OVERVIEW

### Introduction

Saw palmetto is a popular herbal medication and extract derived from the fruit of the low growing, small palm, Serenoa repens, which has fan shaped leaves and is native to Florida and the Southeast United States. Currently, saw palmetto is used mostly for symptoms of benign prostatic hypertrophy. Saw palmetto has been implicated in rare cases of clinically apparent liver injury, but its specific role in causing liver injury remains uncertain.

### Background

Saw palmetto (saw pal met’ toe) is a widely used herbal derived from the fruit of the low growing bushy palm of the same name (Serenoa repens). Native Americans used saw palmetto fruit both as a food as well as an herbal remedy with multiple uses, including as a sedative, diuretic, sleeping aid, expectorant and cough suppressant, aid to lactation, infertility, indigestion and urinary problems. Currently, saw palmetto is one of the most widely used herbal medications and is used largely for symptomatic benign prostatic hypertrophy. Saw palmetto is available in multiple formulations including liquid extracts, tablets, capsules, and as an herbal tea. The active components of palmetto extracts are believed to be the volatile oils and free fatty acids which have activity in inhibiting 5-alpha-reductase and the conversion of testosterone to dihydrotesterone, which has been demonstrated in vitro, but not in human studies. In short term clinical trials, saw palmetto appeared to be beneficial in improving symptoms of prostatic hypertrophy, but it had no effects on prostate size or serum prostatic specific antigen (PSA) levels. In longer term studies, the benefit of saw palmetto in improving urinary symptoms of benign prostatic hypertrophy was less clear. Saw palmetto is available in multiple over-the-counter preparations often in combination with other herbals or dietary supplements, and most commonly for symptoms of urinary hesitancy, urgency or burning. Side effects of saw palmetto are uncommon and mild and may include dizziness, headache, nausea, vomiting, constipation and diarrhea. In most randomized controlled clinical trials, side effects were no more frequent with saw palmetto than with placebo therapy.

### Hepatotoxicity

Chronic therapy with saw palmetto has not been linked to serum enzyme elevations and prospective trials found little or no evidence of liver injury from its administration. However, there have been rare case reports of clinically apparent liver injury attributed to saw palmetto, although in some instances, other possible causes of liver disease were present. In the reported cases, the latency to onset was within 1 to 2 weeks of starting therapy, and clinical features resembled acute viral hepatitis with a hepatocellular pattern of serum enzyme elevations and resolution within 1 to 3 months. Immunoallergic and autoimmune features were not present.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

Saw palmetto extracts have many components, but none of them has been shown to be particularly hepatotoxic. The rare cases of liver injury reported with saw palmetto use have had idiosyncratic features. Saw palmetto has few herb-drug interactions and is not affected by inducers or inhibitors of the cytochrome P450 enzyme system.

### Outcome and Management

Hepatotoxicity from saw palmetto is very rare and cases have been self-limiting upon stopping the herbal. There have been no instances leading to fatalities, liver transplantation, chronic hepatitis, or vanishing bile duct syndrome. Studies of rechallenge have not been reported.

Other Names: Cabbage palm, Sabal

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Saw Palmetto – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/palmetto/ataglance.htm)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Saw Palmetto | 84604-15-9 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 02 April 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; saw palmetto is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; saw palmetto is listed as nonhepatotoxic).
Saw palmetto. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 725-9. (Compilation of short monographs on herbal medications and dietary supplements).
Hamid S, Rojter S, Vierling J. (1997). Protracted cholestatic hepatitis after the use of Prostata. Ann Intern Med. (65 year old man developed jaundice and pruritus 2 weeks after starting an herbal preparation that contained saw palmetto [bilirubin 8.2 mg/dL, ALT 1364 U/L, Alk P 179 U/L, AMA positive, anti-HCV positive, HCV RNA negative], with resolution 3 months after stopping).
Wilt TJ, Ishani A, Stark G, MacDonald R, Lau J, Mulrow C. (1998). Saw palmetto extracts for treatment of benign prostatic hyperplasia: a systematic review. JAMA. (A systematic review of literature on efficacy of saw palmetto for benign prostatic hypertrophy identified 18 trials involving 2939 men and found overall evidence for its efficacy in improving urinary symptoms; side effects were mild, infrequent and similar in frequency with placebo).
De Smet PAGM. (2002). Herbal remedies. N Engl J Med. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; saw palmetto is not discussed).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; saw palmetto is not listed as causing hepatotoxicity).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to saw palmetto).
Bent S, Kane C, Shinohara K, Neuhaus J, Hudes ES, Goldberg H, Avins AL. (2006). Saw palmetto for benign prostatic hyperplasia. N Engl J Med. (Controlled trial of saw palmetto [160 mg twice daily] vs placebo for one year in 225 men with symptomatic benign prostatic hypertrophy found no difference in symptoms, urinary flow rate, prostate size, quality of life or side effects).
Jibrin I, Erinle A, Saidi A, Aliyu ZY. (2006). Saw palmetto-induced pancreatitis. South Med J. (55 year old reformed alcoholic developed pancreatitis after intermittent use of saw palmetto for 4 years [bilirubin not mentioned, ALT 1232 U/L, Alk P 184 U/L, amylase 2152 U/L], with resolution within a few days of stopping herbal).
Singh YN, Devkota AK, Sneeden DC, Singh KK, Halaweish F. (2007). Hepatotoxicity potential of saw palmetto(Serenoa repens) in rats. Phytomedicine. (Treatment of rats for 4 weeks with concentrations of saw palmetto 5 times that recommended in humans did not result in serum ALT elevations, evidence of oxidative stress or hepatic histological abnormalities).
Avins AL, Bent S, Staccone S, Badua E, Padula A, Goldberg H, Neuhaus J, et al. (2008). A detailed safety assessment of a saw palmetto extract. Complement Ther Med. (Detailed analysis of side effects in a controlled trial of saw palmetto [Bent 2006] vs placebo found no overall difference in rates of side effects, no evidence of hepatotoxicity, no change in ALT, AST or bilirubin levels or serious hepatic adverse events in saw palmetto treated subjects).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals but none attributed to saw palmetto).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but none were linked to saw palmetto).
Tacklind J, MacDonald R, Rutks I, Wilt TJ. (2009). Serenoa repens for benign prostatic hyperplasia. Cochrane Database Syst Rev. (Systematic review of medical evidence of efficacy of saw palmetto as therapy of symptoms of benign prostatic hypertrophy; in controlled trials, there was no difference in adverse event rates between saw palmetto and placebo arms).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; saw palmetto is not listed as a potentially hepatotoxic HDS).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found 17 to saw palmetto, but none related to liver injury).
Lapi F, Gallo E, Giocaliere E, Vietri M, Baronti R, Pieraccini G, Tafi A, et al. (2010). Acute liver damage due to Serenoa repens: a case report. Br J Clin Pharmacol. (58 year old man developed abdominal pain and fatigue 1 week after starting saw palmetto in a dose of 900 mg daily [bilirubin 2.0 mg/dL, ALT 1237 U/L, GGT 456 U/L], resolving within 10 days of stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to saw palmetto).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon herbalife and hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids: saw palmetto is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, including one case report attributed to saw palmetto [Lapi 2010]).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury mentions that saw palmetto has been rarely linked to instances of hepatotoxicity).
Avins AL, Lee JY, Meyers CM, Barry MJ, CAMUS Study Group. (2013). Safety and toxicity of saw palmetto in the CAMUS trial. J Urol. (Analysis of the adverse events that arose in a controlled trial of saw palmetto vs placebo in 369 men with symptoms of benign prostatic hypertrophy found no differences in rates of adverse events; ALT elevations occurred in 12-14% of saw palmetto vs 11-17% of placebo recipients).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to HDS, none of which were attributed to saw palmetto).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, saw palmetto was not implicated in any of the cases).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists a single report of hepatotoxicity from saw palmetto [Lapi 2010]).
Asher GN, Corbett AH, Hawke RL. (2017). Common herbal dietary supplement-drug interactions. Am Fam Physician. (Review of herb-drug interactions of the most commonly used herbal supplements, mentions that saw palmetto has not been shown to have effects or to be affected by P450 substrates, inducers or inhibitors).
Vinarov AZ, Spivak LG, Platonova DV, Rapoport LM, Korolev DO. (2019). 15 years' survey of safety and efficacy of Serenoa repens extract in benign prostatic hyperplasia patients with risk of progression. Urologia. (Among 30 patients with benign prostatic hypertrophy treated with saw palmetto [320 mg once daily] for up to 10 years, there was no progression of symptoms and no reported adverse side effects that could be attributed to the herbal supplement).
Ye Z, Huang J, Zhou L, Chen S, Wang Z, Ma L, Wang D, et al. (2019). Efficacy and safety of Serenoa repens extract among patients with benign prostatic hyperplasia in China: a multicenter, randomized, double-blind, placebo-controlled trial. Urology. (Among 354 Chinese patients with benign prostatic hypertrophy treated with saw palmetto [160 mg] or placebo twice daily for 24 weeks, urinary symptoms and peak urinary flow improved more with the herb treatment, while adverse event rates were similar and there were no serious adverse events or mention of ALT elevations or liver related side effects).

## OTHER REFERENCE LINKS

1 Recent References on Saw Palmetto: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Saw+Palmetto+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Saw Palmetto: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Saw+Palmetto)